# Flavoxate

## OVERVIEW

### Introduction

Flavoxate is a synthetic anticholinergic agent that is used for treatment of urinary incontinence and overactive bladder syndrome. Flavoxate has not been implicated in causing liver enzyme elevations or clinically apparent acute liver injury.

### Background

Flavoxate (flay vox' ate) is a synthetic quaternary ammonium anticholinergic which inhibits the muscarinic actions of acetylcholine on autonomic nerve endings, decreasing the smooth muscle tone of bladder and gastrointestinal tract. Flavoxate has broad activity against muscarinic acetylcholine receptors, but its highly polar quaternary ammonium group makes it less likely to cross lipid membranes such as the blood brain barrier, which is believed to decrease the potential for central nervous system effects. Flavoxate increases bladder capacity and decreases urinary frequency and urgency. Flavoxate was approved for use in the United States in 1970 and continues to be used to treat the symptoms of cystitis and overactive bladder syndrome. Flavoxate is available in tablets of 100 mg in several generic forms and previously under the brand name Urispas. The typically recommended oral dose in adults is 100 to 200 mg three or four times daily. Common side effects are those of parasympathetic stimulation and include dryness of the mouth and eyes, decreased sweating, headache, visual blurring, constipation, urinary retention, impotence, tachycardia and palpitations, anxiety, restlessness and in some instances agitation and delusions. Anticholinergic agents can precipitate acute narrow angle glaucoma and acute urinary retention.

### Hepatotoxicity

Like other anticholinergic agents, flavoxate has not been linked to episodes of liver enzyme elevations or clinically apparent liver injury. A major reason for its safety may relate to the low daily dose.

References on the safety and potential hepatotoxicity of anticholinergics are given together after the Overview section on Anticholinergic Agents.

Drug Class: Anticholinergic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Flavoxate – Generic, Urispas®

DRUG CLASS

Anticholinergic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Flavoxate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Flavoxate | 15301-69-6 | C24-H25-N-O4 | Flavoxate Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Flavoxate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Flavoxate/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Flavoxate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Flavoxate)